# Kratom

## OVERVIEW

### Introduction

Kratom is an herbal made from leaves of a tropical evergreen tree (Mitragyna speciosa) that is native to Southeast Asia. Extracts from the leaves of the kratom tree have psychotropic and opioid-like activity, which has led to their use as a recreational drug. Kratom has been linked to rare instances of clinically apparent acute liver injury.

### Background

Kratom is a botanical extract derived from the leaves of a tropical evergreen tree (Mitragyna speciosa), which belongs to the coffee family and is indigenous to Thailand, Myanmar and Malaysia. In Southeast Asia, kratom has been used for decades as an herbal medication to treat chronic pain, increase energy and stamina, treat chronic pain and diarrhea, and as a substitute for opium or for opium withdrawal. The leaves have multiple components, including psychoactive alkaloids that have opioid-like activity. In many Southeast Asian countries, chewing Mitragyna speciosa leaves is a not uncommon practice and not considered addictive. The effects of chewing kratom leaves include enhanced alertness, talkativeness and sociability. Extracts of kratom have been used to treat chronic pain, diarrhea and cough. The psychoactive effects of kratom have led to its use recreationally as a cannabis-like drug. Higher doses can cause agitation, hypertension, dyspnea and confusion. Overdoses of kratom can cause seizures, coma and death. Kratom has become a substance of abuse and it has not been shown to have any beneficial medical uses. The US FDA and the Drug Enforcement Agency have put out notices of concern about use of kratom as a dietary supplement because of safety issues, including adverse effects of respiratory depression, aggression, hallucinations, delusions, insomnia, vomiting and severe withdrawal. Despite these warnings and lack of known medical benefits, kratom has become a popular and widely available herbal product used for opiate withdrawal symptoms and musculoskeletal pain. Several deaths from kratom overdose have been reported.

### Hepatotoxicity

Chronic use of kratom recreationally has been associated with rare instances of acute liver injury. The onset of injury is usually within 1 to 8 weeks of starting regular use of kratom powder or tablets, with symptoms of fatigue, nausea, pruritus and dark urine followed by jaundice. The pattern of liver injury is typically cholestatic or mixed, and it can be severe with serum bilirubin levels rising above 20 mg/dL. The severe cholestasis can be accompanied by acute renal failure and bone marrow toxicity. Fever is common, but not rash or eosinophilia and autoantibodies are usually absent. The cholestasis can be prolonged, but usually resolves spontaneously. Corticosteroids as well as N-acetylcysteine have been used in cases of suspected kratom hepatotoxicity, but their efficacy is unproven. Kratom is a banned substance in many areas of the country and considered an agent of abuse rather than a dietary supplement. At least two dozen cases of clinically apparent liver injury with jaundice have been reported in the literature and a similar number reported to the Food and Drug Administration adverse event database.

Likelihood Score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury due to kratom is unknown. It is often used with other agents, including drugs of abuse, and its causative relationship to liver injury in published cases is not always clear.

### Outcome and Management

Patients who present with acute liver injury due to kratom usually recover once it is discontinued. There is no evidence that corticosteroids shorten the course of illness or improve outcomes. Patients should be warned against further use of kratom and multiingredient nutrition supplements that might contain it.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Kratom – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at DEA, Office of Diversion Control, Drug & Chemical Evaluation Section (https://www.deadiversion.usdoj.gov/drug_chem_info/kratom.pdf)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Kratom | S900005870 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 05 April 2020

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; kratom is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; kratom is not discussed).
Drug Enforcement Administration. Kratom (Mitragyna speciosa korth). https://www.deadiversion.usdoj.gov/drug_chem_info/kratom.pdf (Short description of the chemistry, mechanism of action and potential for abuse and harm from kratom by the Drug Enforcement Administration).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network(DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% were attributed to herbals and dietary supplements, but none to kratom).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 12 [9%] attributed to herbals, but none to kratom).
Nelsen JL, Lapoint J, Hodgman MJ, Aldous KM. (2010). Seizure and coma following Kratom(Mitragynina speciosa Korth) exposure. J Med Toxicol. (64 year old man developed seizures and coma shortly after ingesting kratom tea and datura stramonium [Jimson weed with anticholinergic activity], having high levels of both in urine, awaking after 24 hours and admitting to chronic use of kratom for chronic pain).
Ward J, Rosenbaum C, Hernon C, McCurdy CR, Boyer EW. (2011). Herbal medicines for the management of opioid addiction: safe and effective alternatives to conventional pharmacotherapy?. CNS Drugs. (Review of herbal medications that are used for opioid addiction and withdrawal; there have been no formal trials of the efficacy and safety of kratom for withdrawal symptoms).
Kapp FG, Maurer HH, Auwärter V, Winkelmann M, Hermanns-Clausen M. (2011). Intrahepatic cholestasis following abuse of powdered kratom (Mitragyna speciosa). J Med Toxicol. (25 year old man developed fever and abdominal pain followed by jaundice a week after stopping a 2 week course of kratom powders [bilirubin 31.9 mg/dL, ALT 94 U/L, Alk P 173 U/L], liver biopsy showing bland cholestasis, with slow and spontaneous improvement).
Schmidt MM, Sharma A, Schifano F, Feinmann C. (2011). "Legal highs" on the net-Evaluation of UK-based Websites, products and product information. Forensic Sci Int. (Internet searches for "legal highs" identified several hundred websites offering various products [pills, smoking materials, powders, teas], 92% of which did not list ingredients and 92% failing to mention side effects, most common products being Salvia divinorum and kratom).
Kronstrand R, Roman M, Thelander G, Eriksson A. (2011). Unintentional fatal intoxications with mitragynine and O-desmethyltramadol from the herbal blend Krypton. J Anal Toxicol. (9 cases of fatal overdose of "Krypton" were identified over a 1 year period [2009-2010] in Sweden; 7 men and 2 women, ages 22 to 35 years, found dead or presenting in shock and asystole with lung and brain edema in all and liver steatosis in one; Krypton consists of powder extracts of kratom leaves and the mu-opioid agonist, O-desmethyltramadol, the major active metabolite of tramadol).
Holler JM, Vorce SP, McDonough-Bender PC, Magluilo J, Solomon CJ, Levine B. (2011). A drug toxicity death involving propylhexedrine and mitragynine. J Anal Toxicol. (20 year old man was found dead with no signs of trauma, but a history of kratom ingestion and autopsy showing pulmonary edema and presence of propylhexedrine, and kratom in urine).
Rosenbaum CD, Carreiro SP, Babu KM. (2012). Here today, gone tomorrow... and back again? A review of herbal marijuana alternatives (K2, Spice), synthetic cathinones (bath salts), kratom, Salvia divinorum, methoxetamine, and piperazines. J Med Toxicol. (Review of herbal alternatives to marijuana for euphoric effects, including kratom which has stimulatory effects at low doses and opioid-like effects at higher doses, and is available through the internet as powders, leaves, teas or as tablets, sometimes combined with other opiate-like agents).
Prozialeck WC, Jivan JK, Andurkar SV. (2012). Pharmacology of kratom: an emerging botanical agent with stimulant, analgesic and opioid-like effects. J Am Osteopath Assoc. (Concise review of chemical constituents, pharmacology, clinical effects, uses and safety of kratom).
Forrester MB. (2013). Kratom exposures reported to Texas poison centers. J Addict Dis. (Between 2009 and 2013, there were 14 reports of kratom exposures to the Texas Poison center, but none between 1998 and 2008; adverse events being tachycardia, agitation, nausea, vomiting, tremor, sweating, diaphoresis, drowsiness and hallucinations but no deaths).
Neerman MF, Frost RE, Deking J. (2013). A drug fatality involving Kratom. J Forensic Sci. (17 year old man was found dead with empty bottles and boxes of kratom, autopsy showing bilateral pulmonary edema and high mitragynine blood levels).
Ulbricht C, Costa D, Dao J, Isaac R, LeBlanc YC, Rhoades J, Windsor RC. (2013). An evidence-based systematic review of kratom (Mitragyna speciosa) by the Natural Standard Research Collaboration. J Diet Suppl. (Systematic review of safety and efficacy of kratom [Mitragyna speciosa] concludes that there is a lack of evidence in support of kratom having any clinical indication, its historic uses being as an analgesic, antitussive, anxiolytic, and treatment for opiate withdrawal).
Singh D, Müller CP, Vicknasingam BK. (2014). Kratom (Mitragyna speciosa) dependence, withdrawal symptoms and craving in regular users. Drug Alcohol Depend. (Survey of kratom abuse among 293 Malaysian men, who typically used it 3 times daily, to improve energy, treat pain or avoid opiate use; most were dependent and had a history of withdrawal symptoms if they tried to stop).
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. (2013). Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], and that these other diagnoses weakened the causality assessment in most instances).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period [2010-2011], including 15 [16%] due to herbal and dietary supplements, but none were attributed to kratom).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, the single most commonly implicated herbal agent was green tea extract, two cases occurred in patients taking kratom, although in both instances along with other potential hepatotoxic products).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; kratom is not discussed).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver; kratom is not discussed).
Stickel F, Shouval D. (2015). Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. (Extensive review of liver injury due to HDS, but kratom is not discussed).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea extract but kratom was mentioned among products taken by two subjects with liver injury).
Dorman C, Wong M, Khan A. (2015). Cholestatic hepatitis from prolonged kratom use: a case report. Hepatology. (58 year old man developed jaundice 3 months after starting kratom powder for anxiety [bilirubin 9.7 mg/dL, ALT 79 U/L, Alk P 270 U/L], which resolved upon stopping and recurred one year later 1 month after he restarted kratom [bilirubin 25.6 mg/dL, ALT 106 U/L, Alk P 790 U/L], improving again upon stopping but he was lost to follow up before full recovery was documented).
McIntyre IM, Trochta A, Stolberg S, Campman SC. (2015). Mitragynine 'Kratom' related fatality: a case report with postmortem concentrations. J Anal Toxicol. (24 year old man with depression and alcoholism was found dead in bed, postmortem toxicology showing high plasma levels of mitragynine [kratom], but only therapeutic levels of his medications [venlafaxine, mirtazapine, diphenhydramine], liver autopsy histology not mentioned).
Warner ML, Kaufman NC, Grundmann O. (2016). The pharmacology and toxicology of kratom: from traditional herb to drug of abuse. Int J Legal Med. (Review of the pharmacology and toxicology of kratom, its widespread abuse [even among high school students], its present legal situation which is complicated by variations in restrictions from state to state resulting in its continued availability "via head shops, kava bars and especially the Internet").
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, does not mention kratom).
Avigan MI, Mozersky RP, Seeff LB. (2016). Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci. (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against Hydroxycut, Lipokinetix and OxyELITE Pro when reports of liver injury appeared in postmarketing phase).
Marcus DM. (2016). Dietary supplements: What's in a name? What's in the bottle?. Drug Test Anal. (Commentary on regulation of HDS products concludes: "the marketing of botanical supplements is based on unfounded claims that they are safe and effective", and "there is no reason to take herbal medicines whose composition and benefits are unknown and whose risks are evident").
Pantano F, Tittarelli R, Mannocchi G, Zaami S, Ricci S, Giorgetti R, Terranova D. (2016). Bet al. Hepatotoxicity induced by "the 3Ks": kava, kratom and khat. Int J Mol Sci. (Review of the published literature on the clinical features and pathogenesis of liver injury associated with three herbals – kava, kratom and khat).
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists published cases for multiple agents, but kratom is not mentioned).
Wong LL, Lacar L, Roytman M, Orloff SL. (2017). Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products).
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al., Drug Induced Liver Injury Network (DILIN). (2017). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none of them mentioning kratom as a component).
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. (2017). Liver injury from herbal and dietary supplements. Hepatology. (Review of the problems of liver injury and HDS products and challenges for future research concludes that stronger regulations are needed to address the increasing number of cases of HDS induced liver injury, particularly those linked to use of multiingredient dietary supplements).
Tayabali K, Bolzon C, Foster P, Patel J, Kalim MO. (2018). Kratom: a dangerous player in the opioid crisis. J Community Hosp Intern Med Perspect. (32 year old man developed jaundice after taking 60 tablets of kratom over one week for low back pain [bilirubin 6.3 mg/dL, ALT 365 U/L, Alk P 391 U/L], liver tests improving over the week following discontinuation).
Riverso M, Chang M, Soldevila-Pico C, Lai J, Liu X. (2018). Histologic characterization of kratom use-associated liver injury. Gastroenterology Res. (36 year old man developed dark urine while taking kratom [bilirubin 5.1 mg/dL, ALT 389 U/L, Alk P 304 U/L], which improved after stopping).
Mousa MS, Sephien A, Gutierrez J. (2018). OʼLeary C. N-Acetylcysteine for acute hepatitis induced by kratom herbal tea. Am J Ther. (31 year old man developed fever, fatigue and jaundice after drinking kratom tea daily for 2 weeks for opiate withdrawal symptoms [bilirubin 2.2 mg/dL, ALT 578 U/L, Alk P 191 U/L], given N-acetylcysteine and recovered with normal liver tests 2 months later).
White CM. (2018). Pharmacologic and clinical assessment of kratom. Am J Health Syst Pharm. (Review of the pharmacology and clinical effects of kratom, stressing its opioid agonist effects and abuse potential and that at least 36 deaths have been attributed to its use [usually overdose] as well as at least one case of cholestatic hepatitis).
Riverso M, Chang M, Soldevila-Pico C, Lai J, Liu X. (2018). Histologic characterization of kratom use-associated liver injury. Gastroenterology Res. (38 year old man developed fever followed by dark urine and jaundice while taking kratom [bilirubin 5.1 mg/dL, ALT 389 U/L, Alk P 304 U/L]; a liver biopsy showed acute cholestatic hepatitis, and he improved rapidly upon stopping).
Aldyab M, Ells PF, Bui R, Chapman TD, Lee H. (2019). Kratom-induced cholestatic liver injury mimicking anti-mitochondrial antibody-negative primary biliary cholangitis: a Case Report and Review of Literature. Gastroenterology Res. (40 year old woman developed fever and abdominal pain after taking kratom once weekly for 4 weeks [bilirubin 5.1 mg/dL, ALT 875 U/L, Alk P 162 U/L], resolving within 5 weeks of stopping).
Fernandes CT, Iqbal U, Tighe SP, Ahmed A. (2019). Kratom-induced cholestatic liver injury and its conservative management. J Investig Med High Impact Case Rep. (52 year old man developed fatigue and jaundice several weeks after stopping a 2 month course of kratom for joint pain [bilirubin 23.2 mg/dL, ALT 66 U/L, Alk P 255 U/L], resolving over the following several weeks).
Osborne CS, Overstreet AN, Rockey DC, Schreiner AD. (2019). Drug-induced liver injury caused by kratom use as an alternative pain treatment amid an ongoing opioid epidemic. J Investig Med High Impact Case Rep. (47 year old man developed fever, fatigue and dark urine 3 weeks after starting kratom for pain [bilirubin 5.8 mg/dL, ALT 265 U/L, Alk P 180 U/L] and had a recurrence 9 months later within days of restarting [bilirubin 3.2 mg/dL, ALT 566 U/L, Alk P 211 U/L]).
Palasamudram Shekar S, Rojas EE, D'Angelo CC, Gillenwater SR, Martinez Galvis NP. (2019). Legally lethal kratom: a herbal supplement with overdose potential. J Psychoactive Drugs. (36 year old man took an overdose of kratom [500 grams!] and was found unarousable with agonal breathing and hypotension, laboratory testing showing ALT 3717 U/L [no bilirubin, Alk P or INR given] and 7-hydroxymitragynine in the urine, recovering with intensive care unit management).
Antony A, Lee TP. (2019). Herb-induced liver injury with cholestasis and renal injury secondary to short-term use of Kratom (Mitragyna speciosa). Am J Ther. (70 year old man developed fatigue and nausea followed by jaundice shortly after taking kratom daily for 4 days for pain [at least a week after onset, bilirubin was 33.7 mg/dL, ALT 59 U/L, Alk P 230 U/L], with slow recovery, all liver test values being normal 3 months later).
Schimmel J, Dart RC. (2020). Kratom (Mitragyna Speciosa) liver injury: a comprehensive review. Drugs. (Review of 85 cases of kratom associated liver injury from published literature, abstracts from scientific meetings, reports to the FDA and internet sources, states that the average latency is 21 days, the typical pattern is cholestatic or mixed, but that the frequency, risk factors, pathogenesis and optimal management are unclear).

## OTHER REFERENCE LINKS

1 Recent References on Kratom: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Kratom+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Kratom: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Kratom)